# Milnacipran

## OVERVIEW

### Introduction

Levomilnacipran is a serotonin and norepinephrine reuptake inhibitor used to treat major depressive disorders. Levomilnacipran is an enantiomer of milnacipran, which is used to treat fibromyalgia. Levomilnacipran and milnacipran have been associated with a low rate of transient elevations in serum aminotransferase levels during treatment and with rare instances of clinically apparent acute liver injury with jaundice.

### Background

Levomilnacipran (lee’ voe mil na’ si pran) is an oral serotonin and norepinephrine reuptake inhibitor (SNRI) that is used as a first line therapy of major depression. Levomilnacipran is the more active enantiomer of milnacipran (mil na’ si pran), which is used to treat fibromyalgia. Unlike other SNRIs such as duxoletine and venlafaxine, levomilnacipran is a more potent inhibitor of norepinephrine reuptake than serotonin reuptake. Milnacipran was approved for use in the United States in 2007 and levomilnacipran in 2013. Despite the fact that they are identical in chemical structure, the only official current indication for milnacipran is fibromyalgia, and the sole indication for levomilnacipran is the treatment of major depressive disorders. Levomilnacipran has been evaluated as therapy of fibromyalgia and phantom limb syndrome, but is not approved for those uses. Milnacripran is available in 12.5, 25, 50 and 100 mg tablets and the recommended dosage is 50 mg twice daily after a 7 day titration schedule. Levomilnacipran is available in extended release capsules of 20, 40 80 and 120 mg under the brand name Fetzima. The recommended starting dosage is 20 mg once daily, with titration upwards by 20 mg every 2 days to a maximum daily dose of 120 mg. Common side effects of milnacipran and levomilnacipran include nausea, vomiting, constipation, headache, sweating, increased heart rate, palpitations, testicular pain, urinary hesitancy and erectile dysfunction. When used with other serotonin reuptake inhibitors, milnacipran and levomilnacipran can be associated with acute serotonin syndrome of fever, tachycardia, anxiety and flushing.

### Hepatotoxicity

In large clinical trials, elevations in serum aminotransferase levels during levomilnacipran and milnacipran therapy occurred in 7% of patients, but were usually mild and self-limited. Elevations above 5 times the upper limit of normal (ULN) occurred in ~1% of patients and generally resolved, even without dose adjustment or discontinuation. There has been a single published report of clinically apparent liver injury with jaundice attributed to milnacipran therapy, with a mixed pattern of liver enzyme elevations, transient increases in bilirubin without jaundice, immunoallergic features and rapid recovery on stopping (Case 1).

Likelihood score: D (possible, rare cause of clinically apparent liver injury).

### Mechanism of Injury

Levomilnacipran and milnacipran are metabolized in the liver largely through the CYP 3A4 pathway and liver injury may be related to production of a toxic or immunogenic intermediate. Because of this pathway of metabolism, levomilnacipran and milnacipran are susceptible to drug-drug interactions when used with agents that strongly induce or inhibit CYP 3A4. They can also increase clotting abnormalities in patients on anticoagulants.

### Outcome and Management

Serum aminotransferase elevations above 5 times the upper limit of normal (if confirmed) are rare on milnacipran and levomilnacipran therapy, but should lead to dose reduction or temporary cessation. In patients with clinically apparent liver injury and jaundice, restarting therapy should be done with caution. There does not appear to be cross reactivity with other SNRIs or SSRIs and switching to another antidepressant may be the most appropriate approach. No cases of acute liver failure, chronic hepatitis or vanishing bile duct syndrome have occurred in patients receiving levomilnacipran or milnacipran.

Drug Class: Antidepressants

Other Drugs in the Subclass, SNRIs/SSRIs: Citalopram, Duloxetine, Escitalopram, Fluoxetine, Fluvoxamine, Paroxetine, Sertraline, Venlafaxine, Vilazodone, Vortioxetine

## CASE REPORT

### Case 1. Acute hepatitis due to milnacipran (Ixel).

[Modified from: de Widerspach-Thor A, Dubois F, Bacq Y. [Acute hepatitis associated with milnacipran treatment]. Gastroenterol Clin Biol 2004; 28: 191-2. French. PubMed Citation (https://www.ncbi.nlm.nih.gov/pubmed/15060467)]

A 25 year old woman was hospitalized for epigastric pain and possible jaundice 6 months after starting milnacipran (25 mg daily) for depression. She had a past history of injection drug use and one year previously was found to have anti-HCV without HCV RNA or abnormal liver enzymes. She had been treated chronically with alprazolam for anxiety and buprenorphine for opiate addiction. She denied recent injection drug use, alcohol abuse, travel or other exposures to viral hepatitis. Over a 5 day period, she had developed epigastric pain, nausea, vomiting and headache, followed by dark urine and jaundice. On presentation, she had low grade fever, bruises on her face and cervical, axillary and inguinal lymphadenopathy. Serum ALT levels were 24 times, AST 8.5 times and alkaline phosphatase 4.3 times the upper limit of normal (Table). Serum total bilirubin was slightly above normal (1.3 mg/dL), but direct was elevated (1.0 mg/dL). The prothrombin time and differential white counts were normal. Tests for acute hepatitis A, B and C were negative (including HCV RNA), while tests for anti-HEV were conflicted, IgM anti-HEV being reactive, but IgG anti-HEV being repeatedly negative. Tests for ANA were negative and SMA minimally elevated (1:20). Abdominal ultrasound showed mild celiac adenopathy, but no evidence of biliary obstruction. Milnacipran was discontinued, but alprazolam and buprenophrine were continued. She recovered rapidly, with most enzymes falling into the near normal range within 10 days and all tests being normal 2 months later.

#### Key Points

Medication: | Milnacipran (25 mg daily)
Pattern: | Hepatocellular (R=5.5)
Severity: | 1+ (liver enzyme elevations only)
Latency: | 6 months
Recovery: | Rapid, complete within 2 months
Other medications: | Alprazolam, buprenophrine

#### Laboratory Values

Days After Starting | Days After Stopping | ALT (U/L) | Alk P (U/L) | Bilirubin (mg/dL) | Other
6 months | 0 | 944 | 495 | 1.3 | Symptoms, direct bilirubin 1.0
| 9 days | 76 | 207 | 0.4 | Symptoms resolved
7 months | 1 month | 45 | 126 | 0.4
| 6 weeks | <40 | <115 | 0.4
| 2 months | <40 | <115 | 0.2
| 3 months | <40 | <115 | 0.3
Normal Values | | <40 | <115 | <1.2

* Values expressed as times the upper limit of normal were converted to absolute units.

#### Comment

While milnacipran has been used in Europe as an antidepressant for more than a decade, its use in the United States has been restricted to fibromyalgia. Subsequently, the levorotatory stereoisomer – levomilnacipran – was evaluated and approved for use in major depressive disorders in the United States. Both agents are associated with a low rate of serum aminotransferase elevations during therapy and only rare elevations above 3 times the upper limit of normal. This publication was the initial and, so far, only report of clinically apparent liver injury from milnacipran, and the injury described was transient and mild. The attribution of the injury to milnacipran can only be considered “probable” or “possible”, as the clinical course was also compatible with an acute viral illness or with acute hepatic necrosis (perhaps from buprenorphine or other drug overdose). On the other hand, the clinical symptoms of fever, headache, facial bruising and lymphadenopathy are also compatible with an immunoallergic hepatitis which might have been caused by milnacipran, although the long latency is atypical for immunoallergic reactions.

## PRODUCT INFORMATION

REPRESENTATIVE TRADE NAMES

Levomilnacipran – Fetzima®

Milnacipran – Savella®

DRUG CLASS

Antidepressants

COMPLETE LABELING (https://dailymed.nlm.nih.gov/dailymed/search.cfm?label=all&query=Levomilnacipran)

Product labeling at DailyMed, National Library of Medicine, NIH

## CHEMICAL FORMULAS AND STRUCTURES

DRUG | CAS REGISTRY NO. | MOLECULAR FORMULA | STRUCTURE
Milnacipran | 101152-94-7 | C15-H22-N2-O.Cl-H | Milnacipran structure
Levomilnacipran | 96847-54-0 | C15-H22-N2-O | Levomilnacipran structure

## ANNOTATED BIBLIOGRAPHY

References updated: 20 May 2019

Zimmerman HJ. Hepatotoxicity: the adverse effects of drugs and other chemicals on the liver. 2nd ed. Philadelphia: Lippincott, 1999. (Review of hepatotoxicity published in 1999 before the availability of milnacipran or levomilnacipran).
Larrey D, Ripault M-P. Hepatotoxicity of psychotropic drugs and drugs of abuse. In, Kaplowitz N, DeLeve LD, eds. Drug-induced liver disease. 3rd ed. Amsterdam: Elsevier, 2013, pp. 443-62. (Review of hepatotoxicity of antidepressants mentions that milnacipran has been linked to very rare cases of liver injury).
O'Donnell JM, Shelton RC. Pharmacotherapy of depression and anxiety disorders. In, Brunton LL, Hilal-Dandan R, Knollman BC, eds. Goodman & Gilman's the pharmacological basis of therapeutics. 13th ed. New York: McGraw-Hill, 2018, pp. 267-78. (Textbook of pharmacology and therapeutics).
de Widerspach-Thor A, Dubois F, Bacq Y. [Acute hepatitis associated with milnacipran treatment]. Gastroenterol Clin Biol 2004; 28: 191-2. French. (25 year old woman developed epigastric pain and nausea 6 months after starting milnacipran for depression and while also on buprenorphine and alprazolam [bilirubin 1.3 mg/dL, ALT ~950 U/L, Alk P ~550 U/L], resolving within 1-2 months of stopping milnacipran alone: Case 1). 15060467
Vitton O, Gendreau M, Gendreau J, Kranzler J, Rao SG. A double-blind placebo-controlled trial of milnacipran in the treatment of fibromyalgia. Hum Psychopharmacol 2004; 19 Suppl 1: S27-35. (Among 125 patients with fibromyalgia in a 12 week randomized controlled trial, 7% of 86 patients taking milnacipran developed ALT or AST elevations, but all were less than twice ULN and all resolved without symptoms or bilirubin elevations). 15378666
Clauw DJ, Mease P, Palmer RH, Gendreau RM, Wang Y. Milnacipran for the treatment of fibromyalgia in adults: a 15-week, multicenter, randomized, double-blind, placebo-controlled, multiple-dose clinical trial. Clin Ther 2008; 30: 1988-2004. (Among 1196 patients with fibromyalgia treated with two doses of milnacipran or placebo for 15 weeks, the most common side effects of milnacipran were nausea [34-38%], constipation [14-18%], hot flushes [11-15%], dizziness [9%] and palpitations [7-8%], and there were "no clinically relevant mean changes from baseline in any of the laboratory parameters tested"). 19108787
Mease PJ, Clauw DJ, Gendreau RM, Rao SG, Kranzler J, Chen W, Palmer RH. The efficacy and safety of milnacipran for treatment of fibromyalgia. a randomized, double-blind, placebo-controlled trial. J Rheumatol 2009; 36: 398-409. (Among 888 patients with fibromyalgia treated with two doses of milnacipran or placebo for 27 weeks, the most common side effects were nausea, constipation, sweating, hot flushes, dry mouth, palpitations and hypertension, the "mean changes from baseline in laboratory values were not clinically important," and no hepatic serious adverse events were reported). 19132781
Milnacipran (savella) for fibromyalgia. Med Lett Drugs Ther 2009; 51 (1314): 45-6. (Concise summary of efficacy and safety of milnacipran shortly after its approval for use in the US as therapy of fibromyalgia; mentions that milnacipran has been associated with mild ALT elevations during therapy). 19528885
Reuben A, Koch DG, Lee WM; Acute Liver Failure Study Group. Drug-induced acute liver failure: results of a U.S. multicenter, prospective study. Hepatology 2010; 52: 2065-76. (Among 1198 patients with acute liver failure enrolled in a US prospective study between 1998 and 2007, 133 were attributed to drug induced liver injury, none of which were attributed to milnacipran or levomilnacipran). 20949552
Branco JC, Zachrisson O, Perrot S, Mainguy Y; Multinational Coordinator Study Group. A European multicenter randomized double-blind placebo-controlled monotherapy clinical trial of milnacipran in treatment of fibromyalgia. J Rheumatol 2010; 37: 851-9. (Among 884 patients with fibromyalgia treated with milnacipran or placebo for 17 weeks, common side effects were nausea, excessive sweating and headaches and the discontinuation rate was 22%; no mention of ALT elevations or hepatotoxicity). 20156949
Yacoub HA, Johnson WG, Souayah N. Serotonin syndrome after administration of milnacipran for fibromyalgia. Neurology 2010; 74: 699-700. (76 year old man developed confusion, fever, tachycardia and hypertension 8 days after starting milnacipran and while receiving long term paroxetine; liver tests were not mentioned and he recovered upon stopping the medication). 20177126
Levine M, Truitt CA, O'Connor AD. Cardiotoxicity and serotonin syndrome complicating a milnacipran overdose. J Med Toxicol 2011; 7: 312-6. (59 year old woman took an overdose of milnacipran [3000 mg] and developed stupor, tremor, fever, tachycardia, and respiratory failure requiring intubation, but ultimately recovered, "and liver functions were normal"). 21735310
Levomilnacipran (Fetzima) a new SNRI for depression. Med Lett Drugs Ther 2013; 55 (1432): 101-2. (Concise summary of clinical efficacy, safety and costs of levomilnacipran shortly after its US approval as therapy for major depression; makes no mention of ALT abnormalities). 24419243
Mago R, Forero G, Greenberg WM, Gommoll C, Chen C. Safety and tolerability of levomilnacipran ER in major depressive disorder: results from an open-label, 48-week extension study. Clin Drug Investig 2013; 33: 761-71. (Among 828 patients with major depression enrolled in a 48 week extension study of levomilnacipran, 1 patient developed transient ALT levels >3 times ULN, but without jaundice or need to discontinue treatment). 23999912
Huskey AM, Thomas CC, Waddell JA. Occurrence of milnacipran-associated morbilliform rash and serotonin toxicity. Ann Pharmacother 2013; 47 (7-8): e32. (9 days after starting milnacipran and while also taking fluoxetine, doxepin and tramadol, a 57 year old woman developed full body rash, fever, restlessness, tachycardia and hypertension, the rash resolving within 4 days of stopping; no mention of liver tests results). 23837199
Asnis GM, Bose A, Gommoll CP, Chen C, Greenberg WM. Efficacy and safety of levomilnacipran sustained release 40 mg, 80 mg, or 120 mg in major depressive disorder: a phase 3, randomized, double-blind, placebo-controlled study. J Clin Psychiatry 2013 Mar; 74 (3): 242-8. (Among 704 patients with major depressive disorders treated for 10 weeks with one of 3 doses of levomilnacipran or placebo, mean levels of ALT and AST increased slightly in the levomilnacipran groups and 7 [1.3%] had ALT or AST elevations above 3 times ULN, although none developed jaundice). 23561229
Scott LJ. Levomilnacipran extended-release: a review of its use in adult patients with major depressive disorder. CNS Drugs 2014; 28: 1071-82. (Review of 4 placebo controlled trials of levomilnacipran in 2623 patients with major depressive disorders lists the most common adverse reactions as nausea, constipation, sweating, tachycardia, palpitations, erectile dysfunction and ejaculation disorder, but does not discuss ALT elevations or hepatotoxicity). 25270036
Shiovitz T, Greenberg WM, Chen C, Forero G, Gommoll CP. A randomized, double-blind, placebo-controlled trial of the efficacy and safety of levomilnacipran ER 40-120mg/day for prevention of relapse in patients with major depressive disorder. Innov Clin Neurosci 2014; 11: 10-22. (Among 348 patients with major depressive disorders in a 24 week continuation trial of levomilnacipran, mean levels of ALT, AST and Alk P increased, but there were no "clinically meaningful changes in liver enzymes"). 24653937
Sambunaris A, Bose A, Gommoll CP, Chen C, Greenberg WM, Sheehan DV. A phase III, double-blind, placebo-controlled, flexible-dose study of levomilnacipran extended-release in patients with major depressive disorder. J Clin Psychopharmacol 2014; 34: 47-56. (Among 434 patients with a major depressive disorder treated with 2 doses of levomilnacipran or placebo for 10 weeks, "mean changes for chemistry and hematology parameters were minor"). 24172209
Bakish D, Bose A, Gommoll C, Chen C, Nunez R, Greenberg WM, Liebowitz M, Khan A. Levomilnacipran ER 40 mg and 80 mg in patients with major depressive disorder: a phase III, randomized, double-blind, fixed-dose, placebo-controlled study. J Psychiatry Neurosci 2014; 39: 40-9. (Among 557 patients with major depressive disorders treated with one of 2 doses of levomilnacipran or placebo for 8 weeks, mean ALT, AST and Alk P levels increased slightly in the drug treated groups and 2 patients developed transient ALT levels >3 times ULN, but without jaundice or symptoms). 24144196
Montgomery SA, Gommoll CP, Chen C, Greenberg WM. Efficacy of levomilnacipran extended-release in major depressive disorder: pooled analysis of 5 double-blind, placebo-controlled trials. CNS Spectr 2015; 20 (2): 148-56. (Among 2598 patients with major depressive disorders treated for 8-10 weeks in 5 placebo controlled trials, changes in depression rating scores were greater with levomilnacipran [-15.8] than placebo [-12.9]; no discussion of adverse events). 24902007
Park SH, Ishino R. Liver injury associated with antidepressants. Curr Drug Saf 2013; 8: 207-23. (Review of hepatotoxicity of modern antidepressants, mentions that Milnacipran is a SNRI but approved in the US only for fibromyalgia and that it has not been linked to instances of liver injury in the published literature). 23914755
Deardorff WJ, Grossberg GT. A review of the clinical efficacy, safety and tolerability of the antidepressants vilazodone, levomilnacipran and vortioxetine. Expert Opin Pharmacother 2014; 15: 2525-42. (Review of the safety and efficacy of levomilnacipran mentions the most frequent adverse events were nausea, vomiting, constipation, sweating, erectile dysfunction, tachycardia and palpitations; no mention of ALT elevations or hepatotoxicity). 25224953
Voican CS, Corruble E, Naveau S, Perlemuter G. Antidepressant-induced liver injury: a review for clinicians. Am J Psychiatry 2014; 171: 404-15. (Review of hepatotoxicity of antidepressants, does not discuss milnacipran or levomilnacipran). 24362450
Chalasani N, Bonkovsky HL, Fontana R, Lee W, Stolz A, Talwalkar J, Reddy KR, et al.; United States Drug Induced Liver Injury Network. Features and outcomes of 899 patients with drug-induced liver injury: The DILIN Prospective Study. Gastroenterology 2015; 148: 1340-52.e7. PubMed Citation (https://www.ncbi.nlm.nih.gov/pubmed/25754159) (Among 899 cases of drug induced liver injury enrolled in a US prospective study between 2004 and 2013, 20 cases [2%] were attributed to antidepressants including 9 due to SNRIs including duloxetine [n=7], nefazodone [n=1], trazodone [n=1], and 5 to SSRIs including escitalopram [n=3], fluoxetine [n=1] and sertraline [n=1], but none were attributed to milnacipran or levomilnacipran).
Friedrich ME, Akimova E, Huf W, Konstantinidis A, Papageorgiou K, Winkler D, Toto S, et al. Drug-induced liver injury during antidepressant treatment: results of AMSP, a drug surveillance program. Int J Neuropsychopharmacol 2016; 19. pii: pyv126. PubMed Citation (https://www.ncbi.nlm.nih.gov/pubmed/26721950) (Among 184,234 psychiatric inpatients from 80 hospitals, 149 cases [0.08%] of drug induced liver injury were reported, but none were atributed to milnacipran or levomilnacipran).
Ferrajolo C, Scavone C, Donati M, Bortolami O, Stoppa G, Motola D, Vannacci A, et al.; DILI-IT Study Group. Antidepressant-induced acute liver injury: a case-control study in an Italian inpatient population. Drug Saf 2018; 41: 95-102. PubMed Citation (https://www.ncbi.nlm.nih.gov/pubmed/28770534) (Among 179 cases of hospitalizations for unexplained acute liver injury enrolled in an Italian prospective study between 2010 and 2014, 17 had been exposed to an antidepressant including 4 to citalopram, 3 sertraline, 3 amitriptyline and 2 paroxetine, but none were linked to milnacipran or levomilnacipran).
Billioti de Gage S, Collin C, Le-Tri T, Pariente A, Bégaud B, Verdoux H, Dray-Spira R, et al. Antidepressants and hepatotoxicity: A cohort study among 5 million individuals registered in the French National Health Insurance Database. CNS Drugs 2018; 32: 673-84. (Among 5 million persons identified in a national French health insurance database who started an antidepressant between 2010 and 2015, 382 developed serious liver injury resulting in hospitalization, rates per 100,0000 persons-years being 19 for SSRIs, 22 venlafaxine, 13 duloxetine, and 33 mirtazapine while among 37,577 persons who started milnacipran, there were no hospitalizations for liver injury).29959758

## OTHER REFERENCE LINKS

1. Recent References on Levomilnacipran and Milnacipran: from PubMed.gov (https://www.ncbi.nlm.nih.gov/sites/entrez?cmd=search&db=pubmed&pubmedfilters=true&term=Levomilnacipran+AND+Human%5BMH%5D+AND+(drug+induced+liver+injury+OR+jaundice/CI+OR+bile+duct+diseases/CI+OR+liver/DE+OR+liver+diseases/CI)+AND+(%221900/1/1%22%5BEDat%5D%3A%222999/12/31%22%5BEDat%5D))
2. Trials on Levomilnacipran and Milnacipran: from ClinicalTrials.gov (https://clinicaltrials.gov/ct2/results?term=Levomilnacipran)